# Lemon Balm

## OVERVIEW

### Introduction

Lemon balm is an oily extract of the leaves of Melissa officinalis, a flowering perennial shrub native to the east Mediterranean and west Asian regions that is now cultivated widely. Lemon balm was used in traditional medicine for nervousness, anxiety, insomnia, and menstrual irregularities. Lemon balm extracts are generally recognized as safe and have not been linked to serum aminotransferase elevations during treatment or to instances of clinically apparent acute liver injury.

### Background

Lemon balm is an extract made from the fresh or dried leaves of Melissa officialis, a moderate sized, flowering shrub native to the eastern Mediterranean area and western Asia but now cultivated in many areas of the world. Lemon balm extracts contain aromatic, lemony smelling oils, chief of which are citronellal and geranial. Lemon balm also contains glycosides, caffeic acid derivatives, flavonoids, and triterpene acids. Lemon balm has mild sedative and antispasmodic activities in vitro. Melissa officialis is often included in multiingredient products used to alleviate gastrointestinal symptoms, anxiety, and psychological conditions including depression. Lemon Balm extract is generally well tolerated and has few if any adverse events.

### Hepatotoxicity

Lemon balm extract has not been linked to serum enzyme elevations during therapy, although there have been few prospective studies in humans that have reported on laboratory test results during treatment. In small trials, lemon balm extracts have appeared to be well tolerated with only a few minor adverse non-specific effects (headache, dizziness, bloating), which often have been similar in frequency among persons receiving placebo. Despite widescale use as an herbal supplement, lemon balm extract has not been linked to published instances of clinically apparent liver injury. Lemon balm extracts are often included in multiingredient dietary supplements some of which have been implicated in liver injury, but a specific contribution from lemon balm to the injury could not be established. The frequency of hypersensitivity reactions to lemon balm extract is also not known.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Balm, Common Balm, Honey Plant, Sweet Balm, Sweet Mary, Melissa.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lemon Balm – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Citronellal | 106-23-0 | C10-H18-O | SID: 134971626

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2024

Abbreviations: DSHEA, Dietary Supplement Health and Education Act; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but lemon balm is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention lemon balm).
Lemon Balm (Melissa officinalis). PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp 514-5. (Compilation of short monographs on herbal medications and dietary supplements).
Electronic Code of Federal Regulations. Title 21. Part 182. Substances Generally Recognized As Safe. Available at: https://www.accessdata.fda.gov/scripts/cdrh/cfdocs/cfcfr/CFRSearch.cfm?CFRPart=182 (Listing of botanical and herbal products that are “generally recognized as safe” (GRAS) according to FDA criteria, which permits them to be sold as over-the-counter supplements without prior proof of safety and efficacy).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing lemon balm). 15390328
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to lemon balm). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of lemon balm). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to lemon balm). 20949552
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but lemon balm was not listed or mentioned). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing lemon balm). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea, and none were attributed to lemon balm [see also Navarro et al Hepatology 2014]). 25754159
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products does not mention or list lemon balm). 27070596
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list lemon balm). 27402097
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases, but does not mention a product with lemon balm as a component). 27677775
Taavoni S, Nazem Ekbatani N, Haghani H. Valerian/lemon balm use for sleep disorders during menopause. Complement Ther Clin Pract. 2013;19:193-6. (Among 58 postmenopausal women with decreased sexual desire treated with lemon balm [1 g] or placebo daily for 4 weeks, Pittsburgh Sleep Quality Index scores improved in both groups but more with lemon balm, and “no negative effects were observed”; no mention of ALT levels or hepatotoxicity). 24199972
Jandaghi P, Noroozi M, Ardalani H, Alipour M. Lemon balm: A promising herbal therapy for patients with borderline hyperlipidemia - a randomized double-blind placebo-controlled clinical trial. Complement Ther Med. 2016;26:136-40. (Among 58 adults with hypercholesterolemia treated with lemon balm [3 g] or placebo daily for 12 weeks, minor side effects included occasional headache and dizziness, and total cholesterol levels did not change, although LDL cholesterol decreased in the lemon balm group [139 to 126 mg/dL] but not with placebo [130 to 131 mg/dL] and serum ALT and AST levels did not change with lemon balm treatment). 27261994
Shakeri A, Sahebkar A, Javadi B. Melissa officinalis L. - A review of its traditional uses, phytochemistry and pharmacology. J Ethnopharmacol. 2016;188:204-28. (Review of the botanical characteristics, traditional uses, phytochemistry, pharmacological activities, pharmacokinetics, and toxicity of Melissa officinalis mentions that it is generally well tolerated and adverse events are no more frequent with lemon balm than placebo, uncommon adverse events may include dizziness, headache, nausea, abdominal pain, decreased appetite, and wheezing, but no serious adverse events have been reported and or significant changes in laboratory test results). 27167460
Darvish-Mofrad-Kashani Z, Emaratkar E, Hashem-Dabaghian F, Emadi F, Raisi F, Aliasl J, Kamalinejad M, et al. Effect of Melissa officinalis (lemon balm) on sexual dysfunction in women: a double- blind, randomized, placebo-controlled study. Iran J Pharm Res. 2018;17(Suppl):89-100. (Among 58 women with decreased sexual desire treated with lemon balm [1 g] or placebo daily for 4 weeks, those on lemon balm had improvements in sexual desire, arousal, lubrication, organism, and satisfaction with less pain during intercourse, and adverse events were mild and more frequent with placebo than lemon balm). 29796033
Haybar H, Javid AZ, Haghighizadeh MH, Valizadeh E, Mohaghegh SM, Mohammadzadeh A. The effects of Melissa officinalis supplementation on depression, anxiety, stress, and sleep disorder in patients with chronic stable angina. Clin Nutr ESPEN. 2018;26:47-52. (Among 73 patients with chronic, stable angina pectoris treated with lemon balm [3 g daily] or placebo, symptoms of depression, anxiety and stress decreased more with lemon balm; no mention of adverse events or ALT levels during therapy). 29908682
Mirabi P, Alamolhoda SH, Yazdkhasti M, Mojab F. The effects of lemon balm on menstrual bleeding and the systemic manifestation of dysmenorrhea. Iran J Pharm Res. 2018;17(Suppl2):214-223. (Among 90 students with dysmenorrhea treated with lemon balm [330 mg] or placebo three times daily for two menstrual cycles, symptoms of dysmenorrhea decreased in both groups to a similar degree; no mention of side effects or ALT levels during therapy). 31011354
Watson K, Hatcher D, Good A. A randomised controlled trial of lavender (Lavandula angustifolia) and lemon balm (Melissa officinalis) essential oils for the treatment of agitated behaviour in older people with and without dementia. Complement Ther Med. 2019;42:366-373. (Among 49 nursing home residents treated with lemon balm, lavender, or placebo once daily for 2 weeks in a double blind cross-over design, neither drug was associated with an improvement in behavior and lemon balm and lavender had discordant effects on agitation in those with and without dementia; no mention of adverse events, ALT levels, or liver toxicity). 30670268
Ghazizadeh J, Sadigh-Eteghad S, Marx W, Fakhari A, Hamedeyazdan S, Torbati M, Taheri-Tarighi S, et al. The effects of lemon balm (Melissa officinalis L.) on depression and anxiety in clinical trials: A systematic review and meta-analysis. Phytother Res. 2021;35:6690-6705. (Systematic review of the literature of randomized controlled trials of lemon balm in patients with anxiety or depression or both identified 6 adequately rigorous studies in 435 patients, the metaanalysis showing a slight quantitative effect of lemon balm on acute anxiety and both acute and chronic depression without serious side effects; no mention of ALT elevations or hepatotoxicity). 34449930

## OTHER REFERENCE LINKS

Recent References on Melissa officinalis: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Melissa+officinalis+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Melissa officinalis: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Melissa%20officinalis)